# Mitomycin

## OVERVIEW

### Introduction

Mitomycin is a cytotoxic antibiotic which is used as anticancer therapy of advanced cancers of the stomach and pancreas. Mitomycin in combination with other anticancer agents frequently causes mild-to-moderate serum enzyme elevations during therapy and is capable of causing sinusoidal obstruction syndrome, but mitomycin by itself has not been specifically linked to instances of clinically apparent liver injury with jaundice.

### Background

Mitomycin (mye” toe mye’ sin), which is also called mitomycin-C, is a cytotoxic antibiotic first isolated from Streptococcus caespitosus and later shown to have potent antitumor effects in vitro and in vivo. Mitomycin has clinical activity against several forms of malignancy, and combination therapies that include mitomycin have proven effective in several forms of solid tumors. Mitomycin was approved for use in the United States in 2002 and current formal indications include advanced or disseminated stomach and pancreatic cancer in combination with other antineoplastic. Because of its toxicities, however, mitomycin is now rarely used. Mitomycin is available as a solution or lyophilized powder for injection in vials of varying concentrations generically and under the commercial name Mutamycin. The typical dose of mitomycin varies by indication and is adjusted for body weight and renal function. Side effects of mitomycin include bone marrow suppression, nausea, vomiting, diarrhea, stomatitis, rash, fever and malaise. Uncommon but potentially severe adverse events include hemolytic uremic syndrome, hemolysis, neurological abnormalities, renal failure and interstitial pneumonitis.

### Hepatotoxicity

Chemotherapy with mitomycin in combination with other agents is associated with serum enzyme elevations in a proportion of patients, depending upon the dose and other agents used. ALT elevations during mitomycin therapy are usually asymptomatic and transient and may resolve without dose modification. In many instances, it is difficult to attribute the liver test abnormalities to mitomycin, because of the exposure to other potentially hepatotoxic agents. High doses of mitomycin have been linked to cases of sinusoidal obstruction syndrome, typically presenting with right upper quadrant pain 10 to 30 days after the infusion, followed by weight gain, ascites and liver test abnormalities. Fatalities due to hepatic failure have occurred, but most patients recover within 1 to 3 months of onset. The frequency of sinusoidal obstruction syndrome limits the dosage of mitomycin that can be used in cancer chemotherapy and in myeloablation in preparation for bone marrow transplantation. There have been no convincing instances of acute, clinically apparent idiosyncratic liver injury with jaundice associated with mitomycin therapy.

Likelihood score: B[H] (very likely but now uncommon cause of sinusoid obstruction syndrome when given in high doses and in combination with other cytotoxic agents).

### Mechanism of Injury

Mitomycin can be directly toxic to cells and the transient liver enzyme elevations during therapy, and induction of sinusoidal obstruction syndrome are probably due to direct toxicity to hepatocytes and sinusoidal endothelial cells.

### Outcome and Management

The hepatic injury due to mitomycin varies in severity from mild, transient and asymptomatic liver enzyme elevations to acute liver failure due to sinusoidal obstruction syndrome. There is no satisfactory therapy for sinusoidal obstruction syndrome besides careful management of fluid balance and avoidance of further injury. Sinusoidal obstruction syndrome has become rare, largely due to avoidance of high dose chemotherapy with agents that have been linked with it such as busulfan, cyclosphosphamide and mitomycin. Intravenous defibrotide has been used to treat severe sinusoidal obstruction syndrome with some evidence of partial response.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Antibiotics, Cytotoxic: Bleomycin, Dactinomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitoxantrone, Plicamycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mitomycin – Generic, Mutamycin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mitomycin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Mitomycin | 50-07-7 | C15-H18-N4-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2020

Zimmerman HJ. Antibiotics. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 694-8. (Review of hepatotoxicity published in 1999 mentions that mitomycin produces steatosis in experimental animals and humans, but that this appears less important clinically than its potential for causing sinusoidal obstruction syndrome).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; mitomycin is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Cytotoxic agents. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1167-203. (Textbook of pharmacology and therapeutics).
Kenis Y, Stryckmans P. (1964). Chemotherapia (Basel). (Experience in treating 65 patients with various malignancies with a wide range of doses of mitomycin; one patient developed toxic hepatitis, but no details were provided).
Manheimer LH, Vital J. (1966). Mitomycin-C in the therapy of far-advanced malignant tumors. Cancer. (Among 46 patients with advanced cancer treated with mitomycin, there was "no appreciable effect upon the liver function").
Matsunaga F, Shimoyama T, Mikawa K, Ishiwata J. (1967). Comparative study of methods of administering mitomycin C. Cancer. (A total of 135 patients with inoperable advanced cancers were treated with 3 different regimens of mitomycin; no discussion of ALT elevations or hepatotoxicity).
Moertel CG, Reitemeier RJ, Hahn RG. (1968). Mitomycin C therapy in advanced gastrointestinal cancer. JAMA. (Among 45 patients with advanced cancer treated with 5 day courses of mitomycin and 40 who were treated with long term courses, 3 patients developed severe hepatic decompensation in the context of advanced hepatic carcinomatosis and another developed combined hepatic and severe hematologic injury, both resolving together; few details given).
Moore GE, Bross ID, Ausman R, Nadler S, Jones R, Slack N, Rimm AA. (1968). Effects of mitomycin c (NSC-26980) in 346 patients with advanced cancer. Eastern Clinical Drug Evaluation Program. Cancer Chemother Rep. (Among 346 adults with malignancies given mitomycin C in a single dose regimen, toxicities included hematologic [84%], oral ulceration [2%], nausea and vomiting [22%], diarrhea [10%] and rash [5%]; no mention of hepatotoxicity, jaundice or ALT elevations).
Robert J, Barbier P, Manaster J, Jacobs E. (1968). Hepatotoxicity of cytostatic drugs evaluated by liver function tests and appearance of jaundice. Digestion. (Among 417 courses of chemotherapy in 339 patients with various forms of cancer, elevations in bilirubin levels occurred in 9% and Alk P in 11%, but most could be attributed to other causes).
Yamada E, Tanaka Y, Miyaishi S, Kuroyanagi Y. (1970). Kidoc, Kaneko M. One-shot infusion of non-surgically administered mitomycin C in the celiac artery for liver metastases. Clinical effects. Int Surg. (Among 53 patients with liver metastases treated with arterial infusion of mitomycin [30 mg], objective responses occurred in a proportion of those with gastric cancer, no mention of ALT elevations or hepatotoxicity).
Whittington RM, Close HP. (1970). Clinical experience with mitomycin C (NSC-26980). Cancer Chemother Rep. (Among 281 patients with various malignancies treated with mitomycin in multiple 10 day courses, objective responses occurred in 7%; side effects were largely hematologic and gastrointestinal; no mention of ALT elevations or hepatotoxicity).
Godfrey TE, Wilbur DW. (1972). Clinical experience with mitomycin C in large infrequent doses. Cancer. (Among 106 patients with malignancies treated with intermittent infusions of mitomycin, "liver toxicity was not observed").
Lazarus HM, Gottfried MR, Herzig RH, Phillips GL, Weiner RS, Sarna GP, Fay J, et al. (1982). Veno-occlusive disease of the liver after high-dose mitomycin C therapy and autologous bone marrow transplantation. Cancer. (Among 29 patients with advanced malignancies undergoing autologous bone marrow transplantation after mitomycin ablation [60-90 mg over 3 days], 12 [41%] had rise of serum enzymes above 3 times ULN, 6 [21%] developed sinusoidal obstruction syndrome 15-70 days after the infusions, and 3 [10%] died of liver failure).
Gottfried MR, Sudilovsky O. (1982). Hepatic veno-occlusive disease after high-dose mitomycin C and autologous bone marrow transplantation therapy. Hum Pathol. (Histological description of sinusoidal obstruction syndrome in 3 patients after mitomycin therapy and bone marrow transplantation described by Lazarus [1980]).
Schlangen J, Wils J. (1984). Liver calcifications following hepatic artery infusion with 5-fluorouracil, adriamycin and mitomycin C (FAM). Rofo. (Among 27 patients with hepatic metastases from colorectal cancer treated with intraarterial infusions of fluorouracil, doxorubicin and mitomycin, one developed extensive liver calcifications shown on liver biopsy to be calcifications within necrotic tumor tissue; the patient was asymptomatic and liver test results were not provided).
Shepard KV, Levin B, Karl RC, Faintuch J, DuBrow RA, Hagle M, Cooper RM, Beschorner J, Stablein D. (1985). Therapy for metastatic colorectal cancer with hepatic artery infusion chemotherapy using a subcutaneous implanted pump. J Clin Oncol. (Among 62 patients with colorectal cancer metastatic to the liver who underwent intraarterial infusions of FUDR and either mitomycin or dichloromethotrexate, 26 [49%] developed serum enzyme elevations, half of whom had jaundice).
Karanes C, Ratanatharathorn V, Schilcher RB, Young JD, Emmer D, Hoschner JA, Leichman L, Baker LH. (1986). High-dose mitomycin-C with autologous bone marrow transplantation in patients with refractory malignancies. Influence of dose schedule on pharmacokinetics and nonhematopoietic toxicities. Am J Clin Oncol. (Among 12 patients with advanced malignancies undergoing bone marrow transplantation after high dose mitomycin monotherapy, one died of hepatic failure and sinusoidal obstruction syndrome occurred in at least half of patients, indicating that the frequency of severe hepatic toxicity is too great for mitomycin to be used alone for myeloablation).
Sznol M, Ohnuma T, Holland JF. (1987). Hepatic toxicity of drugs used for hematologic neoplasia. Semin Liver Dis. (Overview of hepatotoxicity of antineoplastic agents, mentions that combination regimens including mitomycin have been linked to instances of sinusoidal obstruction syndrome).
Shepard KV, Levin B, Faintuch J, Doria MI, DuBrow RA, Riddell RH. (1987). Hepatitis in patients receiving intraarterial chemotherapy for metastatic colorectal carcinoma. Am J Clin Oncol. (Among 51 patients with liver metastases from colorectal cancer treated with intraarterial infusions of FUDR and either mitomycin or dichloromethotrexate, 24 [47%] developed hepatitis, and two developed biliary strictures).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, several cases were attributed to antineoplastic agents [such as mercaptopurine, cyclophosphamide, docetaxel, temozolomide, bortezomib and imatinib], but none to mitomycin).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, ten were attributed to antineoplastic agents, but none to plicamycin).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 cases were attributed to antineoplastic agents, but none to plicamycin).

## OTHER REFERENCE LINKS

1 Recent References on Mitomycin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Mitomycin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Mitomycin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mitomycin)